# Benralizumab

## OVERVIEW

### Introduction

Benralizumab is a humanized monoclonal antibody to the interleukin-5 (IL-5) receptor alpha which leads to a decrease in production and maturation of eosinophils and is used therapeutically to reduce allergic symptoms in patients with eosinophilic asthma. Benralizumab has not been associated with serum enzyme elevations during therapy or to instances of clinically apparent drug induced liver injury.

### Background

Benralizumab (ben" ra liz' ue mab) is a recombinant, humanized IgG1 monoclonal antibody to the IL-5 receptor alpha which blocks the cytokine from inducing maturation and proliferation of eosinophils [3,12]. IL-5 is a cytokine growth and stimulating factor which has a selective role in recruiting eosinophils from the bone marrow and promoting their differentiation, activation and survival [4,5]. Both circulating and sputum eosinophils are decreased by benralizumab therapy and these effects are reversed when it is discontinued. Benralizumab therapy has been shown to reduce the requirement for inhaled corticosteroids and lower the frequency of exacerbations of eosinophilic asthma [6-12]. Benralizumab was approved for use in the United States in 2017 for therapy of patients 12 years and above with severe eosinophilic asthma resistant to standard therapy with inhaled corticosteroids. Benralizumab is available in solution in single use syringes of 30 mg under the brand name Fasenra. The recommended dose is 30 mg given subcutaneously every 4 weeks for 3 doses, followed by every 8 weeks thereafter. Side effects are not common, but can include injection site reactions, headache and oropharyngeal pain. Severe adverse reactions attributed to benralizumab include hypersensitivity reactions such as urticaria, angioedema and anaphylaxis, but these are rare [3].

### Hepatotoxicity

In large clinical trials, rates of serum aminotransferase and alkaline phosphatase elevations were similar in patients receiving benralizumab as in those on placebo [6-11]. Indeed, rates of most adverse reactions were similar in patients who received placebo injections or standard care. In prelicensure trials in more than 200 patients, there were no instances of clinically apparent liver injury with jaundice and since its approval and more wide scale use, there have been no published reports of hepatotoxicity attributed to benralizumab therapy. Thus, liver injury from benralizumab must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Benralizumab is a humanized monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are usually metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic [1,2]. Benralizumab lowers serum eosinophil counts, which seems to have no adverse effects on the liver and does not result in significant immunosuppression [5].

Drug Class: Antiasthmatic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Benralizumab – Fasenra®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Benralizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Benralizumab | 1044511-01-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 05 July 2018

Abbreviations: COPD, chronic obstructive pulmonary disease; IL-5, interleukin-5.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents before the availability of benralizumab; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists”).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1031-65. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Ogbogu PU, Bochner BS, Butterfield JH, Gleich GJ, Huss-Marp J, Kahn JE, Leiferman KM, et al. Hypereosinophilic syndrome: a multicenter, retrospective analysis of clinical characteristics and response to therapy. J Allergy Clin Immunol 2009; 124: 1319-25. e3. (Among 188 patients with hypereosinophilic syndrome seen at 11 referral centers in the US between 2001 and 2006, 55% were male, ages 6 to 85 [median=45] years, most patients responded to corticosteroids and resistant cases often responded to therapy with monoclonal antibody to IL5). 19910029
Gleich GJ, Klion AD, Lee JJ, Weller PF. The consequences of not having eosinophils. Allergy 2013; 68: 829-35. (Review data on patients treated with monoclonal antibody to IL5 for several years failed to show any identifiable, long term adverse effects of inhibition or decrease in eosinophil counts). 23742015
Castro M, Wenzel SE, Bleecker ER, Pizzichini E, Kuna P, Busse WW, Gossage DL, et al. Benralizumab, an anti-interleukin 5 receptor α monoclonal antibody, versus placebo for uncontrolled eosinophilic asthma: a phase 2b randomised dose-ranging study. Lancet Respir Med 2014; 2: 879-90. (Among 324 adults with uncontrolled eosinophilic asthma treated with benralizumab [2, 20 or 100 mg every 4-8 weeks] vs placebo, rates of exacerbation were reduced with the 100 mg dose of benralizumab compared to placebo, while adverse event rates were similar except for nasopharyngitis and injection site reactions; no mention of ALT elevations or hepatotoxicity). 25306557
Brightling CE, Bleecker ER, Panettieri RA Jr, Bafadhel M, She D, Ward CK, Xu X, et al. Benralizumab for chronic obstructive pulmonary disease and sputum eosinophilia: a randomised, double-blind, placebo-controlled, phase 2a study. Lancet Respir Med 2014; 2: 891-901. (Among 101 patients with chronic obstructive lung disease and sputum eosinophilia treated with injections of benralizumab [100 mg every 4-8 weeks] or placebo for 48 weeks, rates of acute exacerbation were similar in the two groups as were rates of adverse events). 25208464
Bleecker ER, FitzGerald JM, Chanez P, Papi A, Weinstein SF, Barker P, Sproule S, et al.; SIROCCO study investigators. Efficacy and safety of benralizumab for patients with severe asthma uncontrolled with high-dosage inhaled corticosteroids and long-acting β(2)-agonists (SIROCCO): a randomised, multicentre, placebo-controlled phase 3 trial. Lancet 2016; 388(10056): 2115-27. (Among 1205 patients with severe uncontrolled asthma treated with benralizumab [30 mg every 4 or 8 weeks] or placebo for 48 weeks, rates of exacerbation were lower with benralizumab compared to placebo and the reduction was most clear in those with preexisting eosinophilia; overall and serious adverse event rates were similar in all groups; no mention of ALT elevations or hepatotoxicity). 27609408
FitzGerald JM, Bleecker ER, Nair P, Korn S, Ohta K, Lommatzsch M, Ferguson GT, et al.; CALIMA study investigators. Benralizumab, an anti-interleukin-5 receptor α monoclonal antibody, as add-on treatment for patients with severe, uncontrolled, eosinophilic asthma (CALIMA): a randomised, double-blind, placebo-controlled phase 3 trial. Lancet 2016; 388 (10056): 2128-41. (Among 1306 patients with severe, uncontrolled eosinophilic asthma treated with benralizumab [30 mg in two dose regimens] or placebo for 48 weeks, exacerbation rates were lower with benralizumab while adverse event rates were similar). 27609406
Nixon J, Newbold P, Mustelin T, Anderson GP, Kolbeck R. Monoclonal antibody therapy for the treatment of asthma and chronic obstructive pulmonary disease with eosinophilic inflammation. Pharmacol Ther 2017; 169: 57-77. (Review of the role of eosinophils in asthma and chronic obstructive lung disease and clinical efficacy of monoclonal antibodies to IL5 including reslizumab and mepolizumab). 27773786
Ferguson GT, FitzGerald JM, Bleecker ER, Laviolette M, Bernstein D, LaForce C, Mansfield L, et al.; BISE Study Investigators. Benralizumab for patients with mild to moderate, persistent asthma (BISE): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Respir Med 2017; 5: 568-76. (Among 211 patients with mild-to-moderate asthma treated with benralizumab [30 mg every 4 weeks] or placebo for 12 weeks, improvements in forced expiratory volume and symptoms were minimally better with benralizumab than placebo and adverse event rates were similar). 28545978
Benralizumab (Fasenra) for severe eosinophilic asthma. Med Lett Drugs Ther 2018; 60 (1541): 33-35. (Concise review of the mechanism of action, clinical efficacy, safety and costs of benralizumab shortly after its approval as therapy of eosinophilic asthma in the US; mentions adverse event rates were similar with benralizumab as placebo and does not mention ALT elevations or hepatotoxicity). 29485975

## OTHER REFERENCE LINKS

1. Recent References on Benralizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Benralizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=theophylline)